# Thrombopoietin Receptor Agonists

## OVERVIEW

### Introduction

The thrombopoietin receptor agonists mimic the action of thrombopoietin on its receptor and stimulate the activation, proliferation and maturation of megakaryocytes, resulting in an increase in circulating platelet counts. Thrombopoietin itself acts in this manner, but when recombinant thrombopoietins were used clinically, they were found to cause rebound thrombocytopenia, probably due to induction of anti-thrombopoietin antibodies. For this reason, direct administration of thrombopoietin was abandoned as an approach to treating thrombocytopenia and other approaches to activating the thrombopoietin receptor were sought.

Several thrombopoietin receptor agonists were subsequently developed and are now in clinical use for chronic idiopathic thrombocytopenic purpura (ITP) and for raising platelet counts in persons with thrombocytopenia undergoing surgical procedures or other thrombocytopenic conditions. Eltrombopag, lusutrombopag and avatrombopag are peptide-like, small molecular weight agonists of the thrombopoietin receptor. These agents are given by mouth and result in significant increases in platelet counts in normal persons as well as patients with thrombocytopenia due to hematologic and liver diseases. Romiplostim, in contrast, is a recombinant polypeptide that binds to and activates the thrombopoietin receptor despite having no amino acid homology to native thrombopoietin. It also increases platelet counts in normal subjects as well as patients with chronic ITP but has not been associated with induction of anti-thrombopoietin antibodies.

### ELTROMBOPAG

### Background

Eltrombopag (el trom' boe pag) is a small molecular weight peptide-like molecule that binds to the transmembrane domain of the thrombopoietin receptor and causes its activation and the proliferation and differentiation of megakaryocytes, with a resultant increase in synthesis and release of platelets. In multiple clinical trials, eltrombopag was shown to raise the platelet count in patients with idiopathic thrombocytopenic purpura (ITP), aplastic anemia and cirrhosis due to chronic hepatitis C during interferon therapy. Eltrombopag was the first oral thrombopoietin receptor agonist approved for use in the United States, initially for treatment of ITP iin 2008. The indications have subsequently been expanded to other thrombocytopenic conditions. Eltrombopag is available as tablets of 12.5, 25, 50, 75 and 100 mg under the brand name Promacta. The typical dose is 25 to 50 mg once daily by mouth. The most common side effects include nausea, diarrhea, fatigue, muscle aches, headaches and dizziness. Rare, but potentially serious adverse reactions include vascular occlusions, stroke and myocardial infarction.

### Hepatotoxicity

In clinical trials in patients with ITP, ALT elevations occurred in 10% to 11% of eltrombopag vs 3% to 7% of placebo treated subjects, but the elevations were usually mild and transient, resolving once eltrombopag was discontinued and sometimes even with continued use. Instances in which there was recurrence of serum enzyme elevations with restarting eltrombopag have been reported and several patients were said to have developed serious liver disease on treatment, perhaps as a result of portal vein thrombosis. Because of such reports, eltrombopag has a boxed warning about hepatotoxicity and the possibility of hepatic decompensation when treating patients with chronic hepatitis C, in which situation monitoring of liver tests is recommended. Despite this, there have been no published reports of idiosyncratic clinically apparent liver injury attributable to eltrombopag therapy in the medical literature and the clinical characteristics, timing on onset, pattern of enzyme elevations and response to withdrawal of therapy of the liver injury attributed to the drug have not been described. Furthermore, with the development of more potent antiviral agents for hepatitis C, interferon is now rarely used and the indication for concurrent use of eltrombopag for thrombocytopenia during interferon therapy is rarely encountered.

Likelihood score: E* (suspected, but unproven cause of clinically apparent liver injury).

### Mechanism of Injury

A mechanism of injury that might lead to serum enzyme elevations during eltrombopag therapy is not known. The thrombosis induced by thrombopoietin receptor agonists might cause a hypercoagulable state resulting in portal vein or hepatic vein thrombosis. However, patients with cirrhosis are known to be at increased risk for portal vein thrombosis, independent of thrombopoiesis-stimulating agents. Eltrombopag is metabolized in the liver, largely by the cytochrome P450 system (CYP 1A2, 2C8) and by the uridine diphosphate glucuronosyltransferase transport system (UGT1A1 and 1A3) and can have significant drug-drug interactions, particularly with statins. Eltrombopag should also be taken on an empty stomach at least 1 hour before and 2 hours after a meal.

### Outcome and Management

Serum aminotransferase elevations above 3 times the upper limit of normal (if confirmed and persistent) during eltrombopag therapy should lead to dose reduction or temporary cessation. Enzyme elevations accompanied by jaundice or symptoms should lead to immediate discontinuation. Eltrombopag has not been implicated in cases of acute liver failure, chronic hepatitis or vanishing bile duct syndrome, but has been linked to clinical worsening or decompensation in patients with cirrhosis due to hepatitis C. For this reason, testing for serum aminotransferase and bilirubin levels is recommended before starting eltrombopag and monitoring for changes if symptoms or signs of liver injury arise. There is no reason to suspect any degree of cross sensitivity in risk for hepatic injury among the various thrombopoietin receptor agonists or other hematologic growth factors.

### AVATROMBOPAG

### Background

Avatrombopag (ah" va trom' boe pag) was the second oral thrombopoietin receptor agonist approved as therapy of thrombocytopenia in the United States. Like eltrombopag, avatrombopag is a small molecular weight peptide-like molecule that binds to the thrombopoietin receptor and causes its activation and the proliferation and differentiation of megakaryocytes, with a resultant increase in synthesis and release of platelets. In clinical trials, avatrombopag was shown to raise the platelet count in patients with thrombocytopenia due to cirrhosis and to reduce platelet transfusion requirements during elective invasive procedures. Avatrombopag was approved for use in the United States in 2018 as therapy of thrombocytopenia in adults with chronic liver disease undergoing surgical, radiologic or medical invasive procedures. Avatrombopag is available as tablets of 20 mg under the brand name Doptelet. The typical dose regimen is 40 or 60 mg once daily for 5 days in preparation of a surgical or invasive procedure 5 to 8 days after the last dose. The most common side effects include fever, abdominal pain, nausea, headache, fatigue and peripheral edema. Rare, but potentially serious adverse reactions include arterial or venous thromboses.

### Hepatotoxicity

In clinical trials in patients with liver disease treated with 5 days of avatrombopag or placebo before undergoing procedures, ALT elevations occurred in 1% to 4% of avatrombopag vs 0% to 2% of control subjects, but the elevations were usually mild and transient, resolving once avatrombopag was discontinued. In prelicensure clinical trials, portal vein thrombosis occurred in some patients after avatrombopag therapy, but the frequency was low and only minimally higher than with placebo treatment. Since its approval, there have been no published reports of clinically apparent liver injury attributable to avatrombopag therapy but it has had limited clinical use. In clinical trials of long term use of avatrombopag, such as in ITP, serum enzyme elevations are more frequent.

Likelihood score: E* (suspected, but unproven cause of clinically apparent liver injury).

### Mechanism of Injury

A mechanism of injury that might lead to serum enzyme elevations during avatrombopag therapy is not known. The thrombosis induced by thrombopoietin receptor agonists might cause a hypercoagulable state resulting in portal vein or hepatic vein thrombosis. However, patients with cirrhosis are known to be at increased risk for portal vein thrombosis, independent of thrombopoiesis-stimulating agents. Avatrombopag is metabolized in the liver, largely by the cytochrome P450 system (CYP 3A4, 2C9) and is a weak inducer of 2CP 2C8 and 2C9, but it has not been found to have clinically significant drug-drug interactions with microsomal enzyme modulators.

### Outcome and Management

Serum aminotransferase elevations above 3 times the upper limit of normal (if confirmed and persistent) during avatrombopag therapy should lead to dose reduction or temporary cessation. Enzyme elevations accompanied by jaundice or symptoms should lead to immediate discontinuation. However, because avatrombopag is given for 5 days only, such elevations are quite rare. Avatrombopag has not been implicated in cases of acute liver failure, chronic hepatitis or vanishing bile duct syndrome.

### LUSUTROMBOPAG

### Background

Lusutrombopag (loo" soo trom' boe pag) was the third oral thrombopoietin receptor agonist approved as therapy of thrombocytopenia in the United States. Like eltrombopag and avatrombopag, lusutrombopag is a small molecular weight peptide-like molecule that binds to the thrombopoietin receptor and causes its activation and the proliferation and differentiation of megakaryocytes, with a resultant increase in synthesis and release of platelets. In several clinical trials, lusutrombopag was shown to raise the platelet count in patients with chronic liver disease and cirrhosis and was associated with lower platelet transfusion requirements in cirrhotic patients undergoing invasive surgical, radiologic and medical procedures. Lusutrombopag was approved for use in the United States in 2018 for treatment of thrombocytopenia in adults with chronic liver disease who are scheduled to undergo an invasive procedure. Lusutrombopag is available as tablets of 3 mg under the brand name Mulpleta. The typical dose is 3 mg once daily for 7 days in preparation for a scheduled invasive procedure 2 to 8 days after the last dose. Common side effects may include fever, abdominal pain, nausea, headache, fatigue and peripheral edema. Rare, but potentially serious adverse reactions include arterial or venous occlusions.

### Hepatotoxicity

In clinical trials in patients with liver disease treated with 7 days of lusutrombopag or placebo before undergoing procedures, ALT elevations occurred in 1% of lusutrombopag vs no control subjects, but the elevations were mild and transient, resolving once lusutrombopag was discontinued. In prelicensure clinical trials, portal vein thrombosis occurred in some patients after lusutrombopag therapy, but the frequency was low and similar to that with placebo treatment. Since its approval, there have been no published reports of clinically apparent liver injury attributable lusutrombopag therapy but it has had limited clinical use.

Likelihood score: E* (suspected, but unproven cause of clinically apparent liver injury).

### Mechanism of Injury

A mechanism of injury that might lead to serum enzyme elevations during lusutrombopag therapy is not known. The thrombosis induced by thrombopoietin receptor agonists might cause a hypercoagulable state resulting in portal vein or hepatic vein thrombosis. However, patients with cirrhosis are known to be at increased risk for portal vein thrombosis, independent of thrombopoiesis-stimulating agents. Lusutrombopag is metabolized in the liver to a small extend, largely by oxidation and glucuronidation. It does not induce cytochrome P450 enzymes and has not been implicated in clinically significant drug-drug interactions.

### Outcome and Management

Serum aminotransferase elevations above 3 times the upper limit of normal (if confirmed and persistent) during lusutrombopag therapy should lead to dose reduction or temporary cessation. Enzyme elevations accompanied by jaundice or symptoms should lead to immediate discontinuation. Because it is typically given for 7 days only, such abnormalities are uncommon and rarely require intervention. Lusutrombopag has not been implicated in cases of acute liver failure, chronic hepatitis or vanishing bile duct syndrome.

### ROMIPLOSTIM

### Background

Romiplostim (roe" mi ploe' stim) is a recombinant fusion protein consisting of four linear 14 amino acid peptides fused to the Fc fragment of the human IgG1 heavy chain that binds to the thrombopoietin receptor, despite lack of homology with native thrombopoietin. The fusion polypeptide has a prolonged half-life, but must be administered parenterally. In several clinical trials, romiplostim was shown to raise platelet counts in patients with chronic ITP without inducing anti-thrombopoietin antibodies. Romiplostim was approved for use in ITP in the United States in 2008 and indications have subsequently been expanded to other thrombocytopenic conditions. Romiplostim is available as a solution in vials of 250 and 500 mcg/mL. The typical initial dose is 1 mcg/kg weekly by subcutaneous injection, which can be increased to a maximum of 10 mcg/kg based upon tolerance and effect. The most common side effects include nausea, diarrhea, fatigue, muscle aches, headaches and dizziness. Rare, but potentially serious adverse reactions include vascular occlusions, stroke and myocardial infarction.

### Hepatotoxicity

In clinical trials in patients with ITP, romiplostim was not linked to ALT elevations or to episodes of clinically apparent liver injury. Since its approval and more widespread use, romiplostim has not been linked to cases of hepatic injury.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

A mechanism of injury by which romiplostim might cause liver injury is not known. It is a recombinant polypeptide and is likely metabolized by many tissues including the cells on which it acts. Romiplostim has not been linked to serious drug-drug interactions.

### Outcome and Management

Romiplostim has not been implicated in cases of clinically apparent liver injury, liver failure or chronic hepatitis. Patients who have developed serum enzyme elevations during treatment with eltrombopag have been successfully and safely switched to romiplostim therapy.

Drug Class: Hematologic Growth Factors

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Avatrombopag – Doptelet®

Eltrombopag – Promacta®

Lusutrombopag – Mulpleta®

Romiplostim – Nplate®

DRUG CLASS

Hematologic Growth Factors

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Thrombopoietin%20Receptor%20Agonists)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Avatrombopag | 570406-98-3 | C29-H34-Cl2-N6-O3-S2 | 2D chemical structure of 570406-98-3
Eltrombopag | 496775-61-2 | C25-H22-N4-O4 | Image of Nintedanib Chemical Structure
Lusutrombopag | 1110766-97-6 | C29-H32-Cl2-N2-O5-S | 2D chemical structure of 1110766-97-6
Romiplostim | 267639-76-9 | Protein | Not Available
Thrombopoietin | 9014-42-0 | Protein | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 30 December 2018

Abbreviations: ITP, idiopathic thrombocytopenic purpura.

Zimmerman HJ. Hormonal derivatives and related drugs. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp 555-88. (Review of hepatotoxicity published in 1999; the thrombopoietin receptor agonists are not specifically mentioned).
Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013. (Textbook on hepatotoxicity; thrombopoietin receptor agonists are not discussed).
Kaushansky K, Kipps TJ. Hematopoietic agents: growth factors, minerals and vitamins. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 751-67. (Textbook of pharmacology and therapeutics).
Li J, Yang C, Xia Y, Bertino A, Glaspy J, Roberts M, Kuter DJ. Thrombocytopenia caused by the development of antibodies to thrombopoietin. Blood 2001; 98: 3241-8. (Analysis of 3 subjects who developed thrombocytopenia [<10,000] after 2 to 28 injections of a commercial pegylated recombinant thrombopoietin; identified antibodies to thrombopoietin as the probable cause). 11719360
Kuter DJ, Bussel JB, Lyons RM, Pullarkat V, Gernsheimer TB, Senecal FM, Aledort LM, et al. Efficacy of romiplostim in patients with chronic immune thrombocytopenic purpura: double-blind randomised controlled trial. Lancet 2008; 371: 395-403. (Among 125 patients with ITP treated with standard of case or romiplostim for 24 weeks, side effects more common with the drug included dizziness, insomnia, abdominal and muscle pain; no mention of ALT elevations or hepatotoxicity). 18242413
Bussel JB, Kuter DJ, Pullarkat V, Lyons RM, Guo M, Nichol JL. Safety and efficacy of long-term treatment with romiplostim in thrombocytopenic patients with chronic ITP. Blood 2009; 113 (10): 2161-71. (Among 142 patients with chronic ITP who were treated with romiplostim for up to 3 years, platelet count responses [>50,000] occurred in 87%, but there were 5 serious thrombotic events including one case of portal vein thrombosis). 18981291
Two new drugs for chronic ITP. Med Lett Drugs Ther 2009; 51 (1305): 10-1. (Concise review of the mechanism of action, clinical efficacy, safety and costs of romiplostim and eltrombopag after their approval for use in ITP in the US mentions that liver function test abnormalities occurred in 10% of eltrombopag treated vs 8% of placebo treated patients, and that one developed “grade 4 liver function test abnormalities and died”). 19197233
Kuter DJ, Rummel M, Boccia R, Macik BG, Pabinger I, Selleslag D, Rodeghiero F, et al. Romiplostim or standard of care in patients with immune thrombocytopenia. N Engl J Med 2010; 363: 1889-99. (Among 234 adults with ITP treated with standard of care or romiplostim, bleeding episodes as well as need for splenectomy and blood transfusions were lower in romiplostim treated subjects; one patient receiving standard of care died of hepatic failure; no mention of ALT elevations or hepatotoxicity). 21067381
Kuter DJ. Biology and chemistry of thrombopoietic agents. Semin Hematol 2010 Jul; 47 (3): 243-8. (Review of the structure and mechanism of action of thrombopoietin and the development of two mimetic drugs [eltrombopag and romiplostim] for use in chronic ITP). 20620435
Khellaf M, Michel M, Quittet P, Viallard JF, Alexis M, Roudot-Thoraval F, Cheze S, et al. Romiplostim safety and efficacy for immune thrombocytopenia in clinical practice: 2-year results of 72 adults in a romiplostim compassionate-use program. Blood 2011; 118: 4338-45. (Among 72 patients with ITP treated with romiplostim for at least 2 years, long term platelet response occurred in 65% of patients and common side effects were arthralgias, fatigue and nausea; no mention of ALT elevations or hepatotoxicity). 21832276
Cooper N, Terrinoni I, Newland A. The efficacy and safety of romiplostim in adult patients with chronic immune thrombocytopenia. Ther Adv Hematol 2012; 3: 291-8. (Review of the efficacy and safety of romiplostim in treatment of adults with ITP; no mention of ALT elevations or hepatotoxicity). 23616916
Cheng G. Eltrombopag, a thrombopoietin- receptor agonist in the treatment of adult chronic immune thrombocytopenia: a review of the efficacy and safety profile. Ther Adv Hematol 2012; 3: 155-64. (Review of the efficacy and safety of eltrombopag based upon 5 prospective trials in ITP, reported serum ALT elevations in 10% of eltrombopag vs 3% of placebo recipients, but elevations were usually asymptomatic and transient, often resolving spontaneously; no episodes of serious clinically apparent liver injury). 23556122
Tsukamoto S, Nakaseko C, Takeuchi M, Kumagai K, Komatsu T, Tanaka H, Hara S, et al. Safety and efficacy of romiplostim in patients with eltrombopag-resistant or -intolerant immune thrombocytopenia. Br J Haematol 2013; 163: 286-9. (Among 3 patients with ITP who developed ALT elevations during eltrombopag therapy and who were switched to romiplostim, the liver dysfunction resolved in all). 23862773
Kuter DJ, Bussel JB, Newland A, Baker RI, Lyons RM, Wasser J, Viallard JF, et al. Long-term treatment with romiplostim in patients with chronic immune thrombocytopenia: safety and efficacy. Br J Haematol 2013; 161: 411-23. (Among 292 patients with ITP treated with romiplostim for up to 5 years, thrombotic events occurred in 6.5% including one case of portal vein thrombosis, whose platelet count was 473,000 three days before the event). 23432528
Rodeghiero F, Stasi R, Giagounidis A, Viallard JF, Godeau B, Pabinger I, Cines D, et al. Long-term safety and tolerability of romiplostim in patients with primary immune thrombocytopenia: a pooled analysis of 13 clinical trials. Eur J Haematol 2013; 91 (5): 423-36. (A pooled analysis of long term studies of romiplostim in 653 patients with ITP reported that thrombotic events occurred in 6% on romiplostim and 3.6% on placebo; no mention of ALT elevations or clinically apparent liver injury). 23927437
Kuter DJ. Milestones in understanding platelet production: a historical overview. Br J Haematol 2014; 165: 248-58. (History of the development of agents to increase platelet counts focusing upon eltrombopag and romiplostim). 24528208
Hitchcock IS, Kaushansky K. Thrombopoietin from beginning to end. Br J Haematol 2014; 165: 259-68. (History of discovery of thrombopoietin and evolution of knowledge about its mechanism of action and development of drugs that activate its receptor). 24499199
Prica A, Sholzberg M, Buckstein R. Safety and efficacy of thrombopoietin-receptor agonists in myelodysplastic syndromes: a systematic review and meta-analysis of randomized controlled trials. Br J Haematol 2014; 167: 626-38. (Systematic review identified 5 trials of thrombopoietin receptor agonists in 384 patients with myelodysplastic syndromes; no discussion or mention of ALT elevations or hepatotoxicity in review of safety). 25155450
Kim YK, Lee SS, Jeong SH, Ahn JS, Yang DH, Lee JJ, Kim HJ. Efficacy and safety of eltrombopag in adult refractory immune thrombocytopenia. Blood Res 2015; 50: 19-25. (Among 18 Korean patients with refractory ITP treated with eltrombopag, ALT elevations occurred in 5 and were greater than 5 times ULN in 2, but none required drug discontinuation or developed clinically apparent liver injury). 25830126
Platzbecker U, Wong RS, Verma A, Abboud C, Araujo S, Chiou TJ, Feigert J, et al. Safety and tolerability of eltrombopag versus placebo for treatment of thrombocytopenia in patients with advanced myelodysplastic syndromes or acute myeloid leukaemia: a multicentre, randomised, placebo-controlled, double-blind, phase 1/2 trial. Lancet Haematol 2015: e417-26. (Among 98 patients with low platelet counts due to myelodysplastic syndromes treated with eltrombopag vs placebo, ALT elevations occurred in 9% of treated subjects, but only 1 was above 5 times ULN). 26686043
Grainger JD, Locatelli F, Chotsampancharoen T, Donyush E, Pongtanakul B, Komvilaisak P, Sosothikul D, et al. Eltrombopag for children with chronic immune thrombocytopenia (PETIT2): a randomised, multicentre, placebo-controlled trial. Lancet 2015; 386 (10004): 1649-58. (Among 92 children with chronic ITP treated with eltrombopag or placebo for 13 weeks, adverse events included AST elevations in 6% vs 0%, but only 1 patient had elevations above 5 times ULN). 26231455
Cines DB, Gernsheimer T, Wasser J, Godeau B, Provan D, Lyons R, Altomare I, et al. Integrated analysis of long-term safety in patients with chronic immune thrombocytopaenia (ITP) treated with the thrombopoietin (TPO) receptor agonist romiplostim. Int J Hematol 2015; 102: 259-70. (Pooled analysis of 1059 patients in 14 trials of romiplostim mentions that common side effects were headache and epistaxis and serious adverse events include thromboses and bleeding including 4 cases of portal vein thrombosis; but there were no liver related serious adverse events or deaths). 26201709
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to eltrombopag or romiplostim). 25754159
Vishnu P, Aboulafia DM. Long-term safety and efficacy of romiplostim for treatment of immune thrombocytopenia. J Blood Med 2016; 7: 99-106. (Review of long term safety of romiplostim discusses common symptoms of headache, fatigue, epistaxis and arthralgia, but does not mention ALT elevations or hepatotoxicity). 27307776
Zaja F, Barcellini W, Cantoni S, Carpenedo M, Caparrotti G, Carrai V, Di Renzo N, et al. Thrombopoietin receptor agonists for preparing adult patients with immune thrombocytopenia to splenectomy: results of a retrospective, observational GIMEMA study. Am J Hematol 2016; 91: E293-5. (Among 31 patients with ITP treated with eltrombopag [n=7] or romiplostim [n=24] in preparation of surgery, platelet counts rose from a mean of 11,000 to 114,000/uL, and 29 underwent splenectomy, one developing portal vein thrombosis and one pulmonary embolus). 26910388
Kurokawa T, Murata S, Ohkohchi N. Stable liver function during long-term administration of eltrombopag, a thrombopoietin receptor agonist, in patients with chronic liver disease. Tohoku J Exp Med 2016; 240: 277-9. (Among 5 patients with chronic liver disease and thrombocytopenia treated with eltrombopag for 6 months, all had improvements in platelet counts without worsening of ALT or bilirubin levels). 27928110
González-López TJ, Fernández-Fuertes F, Hernández-Rivas JA, Sánchez-González B, Martínez-Robles V, Alvarez-Román MT, Pérez-Rus G, et al. Efficacy and safety of eltrombopag in persistent and newly diagnosed ITP in clinical practice. Int J Hematol 2017; 106: 508-16. (Among 220 Spanish adults with ITP treated with eltrombopag for up to 15 months, clinical responses occurred in 80% and 10 [5%] had serum enzyme elevations, all of which resolved on dose modification or discontinuation and none were accompanied by symptoms or jaundice). 28667351
Hwang YY, Gill H, Chan TSY, Leung GMK, Cheung CYM, Kwong YL. Eltrombopag in the management of aplastic anaemia: real-world experience in a non-trial setting. Hematology 2018 Jan 5:1-6. (Among 20 patients with aplastic anemia treated with eltrombopag, 90% had an objective response, but all also had skin discoloration; no mention of ALT elevations or hepatotoxicity). 29303047
Terrault NA, Hassanein T, Howell CD, Joshi S, Lake J, Sher L, Vargas H, et al. Phase II study of avatrombopag in thrombocytopenic patients with cirrhosis undergoing an elective procedure. J Hepatol 2014; 61: 1253-9. (Among 130 patients with cirrhosis and thrombocytopenia undergoing an elective procedure who were treated with 3 different dose-regimens of avatrombopag or placebo for 7 days, platelet counts rose in a greater proportion of avatrombopag than placebo recipients and 1 subject developed portal vein thrombosis 4 weeks after avatrombopag treatment). 25048952
Bussel JB, Kuter DJ, Aledort LM, Kessler CM, Cuker A, Pendergrass KB, Tang S, et al. A randomized trial of avatrombopag, an investigational thrombopoietin-receptor agonist, in persistent and chronic immune thrombocytopenia. Blood 2014; 123: 3887-94. (Among 64 patients with chronic ITP treated with different doses of avatrombopag or placebo for 28 days, platelet counts rose in 13-80% of active drug- vs 0% of placebo-recipients and elevations were maintained for 24 weeks in an extension phase, while adverse were mostly mild-to-moderate and there were no reported severe hepatic adverse events). 24802775
Bussel JB, de Miguel PG, Despotovic JM, Grainger JD, Sevilla J, Blanchette VS, Krishnamurti L, et al. Eltrombopag for the treatment of children with persistent and chronic immune thrombocytopenia (PETIT): a randomised, multicentre, placebo-controlled study. Lancet Haematol 2015; 2: e315-25. (Among 67 children with chronic ITP enrolled in a 3-phase controlled study, eltrombopag recipients were more likely to have a platelet response and have reduced bleeding episodes than those on placebo, and adverse event rates were similar, but 3 subjects on eltrombopag had ALT elevations above 3 times ULN but all resolved, 2 upon discontinuation and one without dose modification). 26688484
Eltrombopag (Revolade ) and thrombocytopenia in patients with hepatitis C. hepatotoxic drug; more harms than benefits. Prescrire Int 2015; 24: 208-9. (Commentary on reports to national registries of hepatic decompensation in patients with chronic hepatitis C receiving eltrombopag while being treated with peginterferon and ribavirin, suggesting caution in its use). 26417629
Choy KW, Wijeratne N, Doery JC. Eltrombopag: liver toxicity, kidney injury or assay interference? Pathology 2016; 48: 754-6. (Eltrombopag is a highly colored drug which is brown in alkaline and yellow in acidic pH, colors which can interfere with spectrophotometric assays for bilirubin, creatinine and phosphate). 27780601
Kim ES. Lusutrombopag: First global approval. Drugs 2016; 76: 155-8. (Review of the mechanism of action, history of development, pharmacology, clinical efficacy and safety of lusutrombopag; no mention of ALT elevations or hepatotoxicity). 26666417
Terrault N, Chen YC, Izumi N, Kayali Z, Mitrut P, Tak WY, Allen LF, Hassanein T. Avatrombopag before procedures reduces need for platelet transfusion in patients with chronic liver disease and thrombocytopenia. Gastroenterology 2018; 155: 705-18. (Among 435 pateints with chronic liver disease and thrombocytopenia treated with 5 days of oral avatrombopag or placebo before undergoing an elective procedure, platelet counts rose higher and need for platelet transfusions were less with active drug than placebo, while adverse event rates were similar although 2 patients receiving avatrombopag developed portal vein thrombosis and 2 died [hepatic coma and multiorgan failure]). 29778606
Jurczak W, Chojnowski K, Mayer J, Krawczyk K, Jamieson BD, Tian W, Allen LF. Phase 3 randomised study of avatrombopag, a novel thrombopoietin receptor agonist for the treatment of chronic immune thrombocytopenia. Br J Haematol 2018; 183: 479-90. (Among 49 adults with ITP in a 26-week randomized controlled trial, platelet counts increased in those on avatrombopag but not on placebo, and “assessment of …clinical laboratory evaluations… identified no safety signal”; one patient had ALT elevations above 5 times ULN but had underlying fatty liver and hepatitis C). 30191972
Shirley M. Avatrombopag: first global approval. Drugs 2018 Jul 11. [Epub ahead of print] (Review of the history of development, mechanism of action, clinical efficacy and safety of avatrombopag shortly after its approval in the US; mentions that 2 cases of portal vein thrombosis occurred in the trials of its use in patients with chronic liver disease, but "there was no evidence... that avatrombopag was associated with hepatotoxicity"). 29995177
Marano M, Serafinelli J, Cairoli S, Martinelli D, Pisani M, Palumbo G, Cefalo MG, et al. Eltrombopag-induced acute liver failure in a pediatric patient: a pharmacokinetic and pharmacogenetic analysis. Ther Drug Monit 2018; 40: 386-8. (3 year old girl with ITP treated with eltrombopag for 6 months developed lactic acidosis, hyperammonemia and abnormal liver tests [bilirubin 2.2 mg/dL, ALT 293 U/L, INR 9.2] with high serum eltrombopag levels, recovering after stopping drug and later found to have variant alleles in drug metabolizing enzymes, CYP2C8, UGT1A1 and ABCG2). 29683873
Loffredo L, Violi F. Thrombopoietin receptor agonists and risk of portal vein thrombosis in patients with liver disease and thrombocytopenia: A meta-analysis. Dig Liver Dis 2018 Jun 20. pii: S1590-8658(18)30792-8. (Among 1953 patients with chronic liver disease and thrombocytopenia treated with a thrombopoietin receptor agonist in 4 randomized controlled trials, the pooled incidence of portal vein thrombosis was 1.6% on active drug vs 0.6% on placebo [p=0.055], while rates of arterial and venous thromboembolic events were 3.6% vs 1.1% [p=0.003]). 29958825

## OTHER REFERENCE LINKS

1. Recent References on Thrombopoietin Receptor Agonists: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Thrombopoietin+Receptor+Agonists+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Thrombopoietin Receptor Agonists: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Thrombopoietin%22Receptor%22Agonists)